# Indomethacin

## OVERVIEW

### Introduction

Indomethacin is a potent nonsteroidal antiinflammatory drug (NSAID) typically used for chronic inflammatory arthritis. Indomethacin has been associated with rare cases of idiosyncratic drug induced liver disease.

### Background

Indomethacin (in" doe meth' a sin) is a methylated indole and belongs to the acetic acid derivative class of NSAIDs similar to diclofenac and etodolac. Like other NSAIDs, indomethacin has antipyretic, analgesic and antiinflammatory activities. The NSAIDs owe their therapeutic effects to the inhibition of intracellular cyclooxygenases (Cox-1 and Cox-2), resulting in decrease in synthesis of proinflammatory prostaglandins which are potent mediators of pain and inflammation. Indomethacin was approved for use in the United States in 1965 and it continues to be used, with more than one half a million prescriptions filled yearly. Indomethacin is indicated for management of various forms of chronic arthritis, including osteoarthritis, rheumatoid arthritis, ankylosing spondylitis, and gouty arthritis, as well as acute shoulder pain (bursitis). Intravenous formulations of indomethacin are approved for the special indication of closure of patent ductus arteriosis in premature infants. Indomethacin is available by prescription as capsules of 25, 50 and 75 mg, in regular and sustained release forms, as suppositories and as suspensions for oral use, in multiple generic forms as well as under several commercial names, including Indocin, Indochron, Indolar, Indo-Lemmon and Zendole. The recommended dosage in adults with chronic arthritis is 25 to 50 mg taken orally two to three times daily, increasing the dose until the symptoms are controlled or a maximum dose of 200 mg is reached. Recommendations for extended release formulations are 75 mg once or twice daily. Injectible formulations of indomethacin are available in single dose 1 mg vials for intravenous use in premature infants with patent ducutus arteriosis. Non-hepatic side effects of indomethacin include headache, dizziness, somnolence, dyspepsia, abdominal discomfort, diarrhea, peripheral edema and hypersensitivity reactions. As with other NSAIDS, indomethacin has potential serious adverse effects, including severe gastrointestinal complications [such as ulcers, bleeding, or perforation], increased risk of cardiovascular thrombotic events [such as myocardial infarction or stoke], renal dysfunction, heart failure and edema, exacerbation of asthma, infertility, fetal toxicity and hypersensitivity reactions.

### Hepatotoxicity

Mild and transient elevations in serum aminotransferase levels are found in up to 15% of patients taking indomethacin chronically. Moderate ALT elevations (>3 times ULN) occur in less than 1% of patients. Frank liver injury with jaundice from indomethacin is rare (estimated at 1.1 per 100,000 prescriptions), and fewer than a dozen cases have been reported in the literature. The latency to onset of symptoms or jaundice is variable, but is usually within 1 to 8 weeks of starting, although instances of latency of 4 to 6 months have been reported. Patients present with anorexia, nausea and vomiting followed by jaundice. Hepatocellular patterns of enzyme elevations are most common, but cholestatic and mixed patterns have been reported. Allergic manifestations and autoimmune features are not common. The injury is usually self-limited, resolving in 1 to 3 months, but several fatal cases have been reported (Case 1), particularly after use of high doses in patients with juvenile rheumatoid arthritis or Still disease. Many of the reported cases of severe indomethacin associated hepatotoxicity have occurred in patients with a pre-existing, underlying chronic liver disease.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which indomethacin induces liver injury is not known, but is likely to be mediated by a toxic intermediate of its metabolism.

### Severity and Recovery

Drug induced liver injury from indomethacin is usually mild-to-moderate in severity and transient, but can progress to acute liver failure and death. In large case series, indomethacin is rarely mentioned as a cause of acute liver failure. Rechallenge may lead to recurrence and should be avoided. Cross sensitivity to hepatic injury among the various NSAIDs has not been well defined. After clinically apparent hepatic injury from indomethacin, acetic acid related NSAIDs (sulindac, diclofenac, etodolac, tolmetin among others) might best be avoided, and those belonging to other classes administered with caution.

Drug Class: Nonsteroidal Antiinflammatory Drugs

## CASE REPORTS

### Case 1. Acute liver failure attributed to indomethacin therapy.(1)

A 40 year old man developed jaundice and dark urine two months after starting indomethacin for adult Still disease. The patient was known to have splenomegaly and alkaline phosphatase and GGT elevations with minimal elevations in aminotransferase levels and normal direct and total bilirubin before therapy (Table). A liver biopsy showed nonspecific changes and activation of macrophages, findings that were attributed to his adult Still disease. He was initially treated with aminopyrine (1.5 g/day) and 6 weeks later indomethacin (100 mg/day) was added. On admission, 8 weeks after starting indomethacin, he had jaundice and prominent hepatomegaly. Serum aminotransferase levels and bilirubin were markedly elevated while alkaline phosphatase and GGT were less than pretreatment values. He had no fever or rash and eosinophil counts were normal. Despite stopping both indomethacin and aminopyrine promptly, jaundice deepened, and he developed hepatic encephalopathy, gastrointestinal bleeding and multiorgan failure, and died two weeks after admission. Autopsy showed hepatosplenomegaly and portal hypertension with superimposed massive hepatic necrosis. The biliary tree was normal without obstruction.

#### Key Points

Medication: | Indomethacin (100 mg daily)
Pattern: | Hepatocellular (R=9.5)
Severity: | 5+ (death from acute liver failure)
Latency: | 2 months
Recovery: | No
Other medications: | Aminopyrine (aminophenazone) 1.5 g/day for 3.5 months.

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 38 | 76 | 0.5 | Liver biopsy
| | Indomethacin started (100 mg/day)
8 weeks | 0 | 550 | 34 | 15.6
9 weeks | 1 weeks | 539 | 26 | 25.8
10 weeks | 2 weeks | 672 | 23 | 30.8
| | Death from multi-organ failure
Normal Values | | <20 | <12 | <1.2

#### Comment

A striking instance of acute liver failure arising two months after initiation of indomethacin therapy. An important feature was that the patient had an underlying liver disease before starting indomethacin, which was attributed to nonspecific effects of Still disease. Thus, the clinical phenotype is more similar to "acute-on-chronic" hepatic injury. In retrospect, the patient may have had nodular regenerative hyperplasia, which would account for the hepatosplenomegaly and minor aminotransferase and more marked alkaline phosphatase elevations. As such, the patient would be more susceptible to a poor outcome from acute hepatocellular injury due to a medication. Another factor complicating the interpretation was use of aminopyrine (also called aminophenazone), another antiinflammatory NSAID which has been abandoned because of toxicity (renal and gastric). Causality assessment would probably designate this case as "possible" or at most "probable" indomethacin induced hepatic injury.

### Case 2. Acute hepatitis due to indomethacin therapy.(2)

A 55 year old man developed weakness, anorexia and abdominal pain followed by dark urine and jaundice and dark urine 3 weeks after starting indomethacin (125 mg daily) for painful heel spurs. A week after initial symptoms, blood tests showed an acute hepatitis, and indomethacin was stopped. He had no history of liver disease, adverse drug reactions, alcohol abuse or risk factors for viral hepatitis. He was taking no other medications. He continued to worsen over the next several weeks and has admitted for evaluation. On examination, he was deeply jaundiced with generalized pruritus and tender hepatomegaly but no rash, fever, or other signs of chronic liver disease or hepatic failure. Laboratory testing showed marked elevation in serum bilirubin and a hepatocellular pattern of serum enzyme elevations with prolongation of the prothrombin time (Table). Tests for hepatitis A and B were negative as was serology of Ebstein-Barr virus and cytomegalovirus infection. Abdominal ultrasound showed no evidence of biliary obstruction. Liver biopsy was refused. With routine medical management, he improved rapidly. When seen in follow up 4 months later, he was asymptomatic and liver tests were normal.

### Key Points

Medication: | Indomethacin (125 mg daily)
Pattern: | Hepatocellular (R=23.7)
Severity: | 4+ (jaundice, hospitalization, coagulopathy)
Latency: | 3 weeks
Recovery: | 4 months
Other medications: | None

### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
4 weeks | 0 | 1070 | - | 9.9 | Indomethacin stopped
6 weeks | 16 days | 520 | 77 | 23.7 | Protime 25%
| 19 days | 770 | 175 | 35.0
7 weeks | 26 days | 205 | 102 | 12.0 | Protime 75%
3 months | 2 months | 24 | 55 | 2.9
6 months | 5 months | 44 | 56 | 0.9
Normal values | | <45 | <115 | <1.2

### Comment

This patient developed a moderately severe acute hepatitis starting 3 weeks after initiation of indomethacin therapy. Other causes of liver injury were adequately excluded, although tests for hepatitis C and E were not available at the time (1985). The pattern of enzyme elevations was distinctly hepatocellular even though cholestasis was present with deep jaundice and pruritus.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Indomethacin – Generic, Indocin®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=indomethacin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Indomethacin | 53-86-1 | C19-H16-Cl-N-O4

## CITED REFERENCES

1 de Kraker-Sangster M, Bronkhorst FB, Brandt KH, Boersma JW. [Massive liver cell necrosis following administration of indomethacin in combination with aminophenzone] Ned Tijdschr Geneeskd 1981; 125: 1828-31. Dutch. 7300940
2 López Navidad A, Cadafalch Arpa J, Vehi Gasol C, Espinos Pérez J. [Acute hepatitis caused by indomethacin] Rev Esp Enferm Apar Dig 1987; 71: 358-9. Spanish. 3602573

## ANNOTATED BIBLIOGRAPHY

References updated: 05 August 2025

Abbreviations used; NSAIDS, nonsteroidal antiinflammatory drugs.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-553. (Expert review of hepatotoxicity published in 1999; indomethacin has been linked to rare instances of hepatocellular injury, but appears to have a lower rate of hepatotoxicity than other NSAIDs).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 369-401. (Review of hepatotoxicity of NSAIDs published in 2013; indomethacin has been available in the US since 1963, but only a few instances of jaundice have been reported with its use).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709. (Textbook of pharmacology and therapeutics; indomethacin is an acetic acid derivative that is 20 times more potent that aspirin, but its long-term use is limited by a high rate of intolerance).
Mandelli F, Ronchi F, Liotta S. [Hepatic function in the course of therapy with indomethacin] Minerva Med 1966; 57: 3020-5. Italian. PMID: 5296945 (Serial tests of hepatic function [largely BSP excretion] carried out in ten patients during indomethacin therapy showed transient changes that reversed with stopping; no case of hepatotoxicity).
Boardman PL, Hart FD. Side-effects of indomethacin. Ann Rheum Dis 1967; 26: 127-32. (Discussion of side effects of indomethacin based upon results in 228 patients treated for an average of 15 weeks; side effects reported in ~50% of patients; headaches, dizziness, dyspepsia, nausea and “muzziness” were common, rarely severe; no mention of liver related side effects). 6023693
Fenech FF, Bannister WH, Grech JL. Hepatitis with biliverdinaemia in association with indomethacin therapy. Br Med J 1967; 3: 155-6. (46 year old man developed biliverdinemia and green urine 3 weeks after starting indomethacin [bilirubin 3.3 mg/dL, ALT 94 U/L, Alk P 55 KA [~4 times ULN], biliverdin in urine], resolving with prednisone therapy in 2 months). 6028104
Guerra M. Toxicity of indomethacin. Report of a case of acute pancreatitis. JAMA 1967; 200: 552-3. (69 year old non-alcoholic man developed acute pancreatitis 3 months after starting indomethacin [AST 95 U/L, amylase 648 U/L] and recovery in next 3 weeks; no mention of jaundice). 6071455
Jacobs JS. Sudden death in arthritic children receiving large doses of indomethacin. JAMA 1967; 199: 932-4. (Two children with juvenile rheumatoid arthritis, ages 6 and 9 years, on indomethacin for 8 and 14 months developed sudden onset of an acute illness with fever, rapid clinical deterioration and death; autopsies did not reveal an obvious cause, but neither appeared to have acute liver injury). 6071563
Kelsey WM, Scharyj M. Fatal hepatitis probably due to indomethacin. JAMA 1967; 199: 586-7. (12 year old boy with juvenile rheumatoid arthritis developed rectal bleeding followed by jaundice and multiorgan failure 8 months after starting indomethacin and prednisone [bilirubin 23.3 mg/dL, ALT 100 U/L, protime 19 sec], and died 10 days later with autopsy showing centrozonal necrosis and microsteatosis). 6071328
Cuthbert MF. Adverse reactions to non-steroidal antirheumatic drugs. Curr Med Res Opin 1974; 2: 600-10. (Analysis of adverse event reporting in UK for NSAIDs, 1964-1973, for indomethacin major events were gastrointestinal upset and hemorrhage, blood dyscrasias, headaches, vertigo, confusion; hepatic reactions accounted for ~3% of nonfatal and 6% [~7 of 114] of fatal indomethacin related reports). 4452298
Siegmund H. [Intrahepatic cholestasis following treatment with D-penicillamine and indomethacin] Med Welt 1976; 27: 172-3. German. PMID: 1250131 (38 year old woman developed jaundice 6 weeks after starting indomethacin and d-penicilliamine for rheumatoid arthritis [bilirubin 5.5 mg/dL, ALT 120 U/L, Alk P 22 “BE” units], resolving within 3 weeks of stopping both).
Borbás B, Kiss E, Varga M. [2 cases of acute liver damage caused by indomethacin] Orv Hetil 1980; 121: 459-60. Hungarian. PMID: 7383683
de Kraker-Sangster M, Bronkhorst FB, Brandt KH, Boersma JW. [Massive liver cell necrosis following administration of indomethacin in combination with aminophenzone] Ned Tijdschr Geneeskd 1981; 125: 1828-31. Dutch. PMID: 7300940 (40 year old man with Still disease developed acute liver failure 2 months after starting indomethacin [bilirubin 15.6 mg/dL, ALT 805 U/L, Alk P 3 times ULN]; also on aminophenazone: Case 1).
Pina R, Lopez-Aldeguer J, Navarro JR, Perez Agullar F, Berenguer J. [Acute hepatitis due to indomethacin] Gastroenterol Hepatol 1981; 4: 49-51. Spanish. Not in PubMed. (43 year old woman developed jaundice and pruritus 15 days after starting indomethacin for joint aches [bilirubin 2.2 mg/dL, AST 860 U/L, Alk P 314 U/L], resolving within 50 days of stopping).
Lopez Vivancos J, Vilaseca J, Arnau JM, Allende E. [Acute cholestatic hepatitis caused by indomethacin] Gastroenterol Hepatol 1985; 8: 165-6. Spanish. Not in PubMed (38 year old woman developed jaundice 3 weeks after starting indomethacin [bilirubin 12.5 rising to 26.3 mg/dL, ALT 3960 U/L, Alk 246 U/L], resolving within 3 months of stopping).
Balduck N, Otten J, Verbruggen L, Bougatef A, Ramet J, Piepsz A. Sudden death of a child with juvenile chronic arthritis, probably due to indomethacin. Eur J Pediatr 1987; 146: 620. (14 year old boy with juvenile rheumatoid arthritis developed jaundice 4 months after starting indomethacin and prednisone [ALT 1426 U/L, bilirubin 25.7 mg/dL], with progressive liver failure and death 10 days later; autopsy showed massive necrosis). 3428300
López Navidad A, Cadafalch Arpa J, Vehi Gasol C, Espinos Pérez J. [Acute hepatitis caused by indomethacin] Rev Esp Enferm Apar Dig 1987; 71: 358-9. Spanish. PMID: 3602573 (55 year old man developed jaundice 3 weeks after starting indomethacin [bilirubin 9.9 rising to 35 mg/dL, ALT 1070 U/L, Alk P 77 U/L], resolving within 2 months of stopping indomethacin: Case 2).
Cappell MS, Kozicky O, Competiello LS. Indomethacin-associated cholestasis. J Clin Gastroenterol 1988; 10: 445-7. (52 year old woman developed asymptomatic elevations in ALT [11 rising to 95 U/L] and Alk P [95 to 268 U/L] without jaundice 10 days after starting indomethacin, resolving rapidly upon stopping). 3047224
Zimmerman HJ. Update of hepatotoxicity due to classes of drugs in common clinical use: non-steroidal drugs, anti-inflammatory drugs, antibiotics, antihypertensives, and cardiac and psychotropic agents. Semin Liver Dis 1990; 10: 322-38. (Review of NSAID and other forms of liver injury). 2281340
Suárez González A, Rodríguez García M, González González M, Alvarez Navascues C, González Sotorrio N, Rodrigo Sáez L. [Acute indomethacin-induced hepatitis in a female patient with asymptomatic primary biliary cirrhosis] An Med Interna 1994; 11: 549-50. Spanish. PMID: 7654905 (51 year old woman developed jaundice 2 weeks after starting indomethacin [bilirubin 20.1 mg/dL, ALT 916 U/L, Alk P 878 U/L, GGT 211 U/L], resolving within 3 months of stopping, but found to have persistent Alk P elevations [~450 U/L] and AMA 1:80 with biopsy findings of primary biliary cirrhosis).
Walker AM. Quantitative studies of the risk of serious hepatic injury in persons using nonsteroidal antiinflammatory drugs. Arthritis Rheum 1997; 40: 201-8. (Review of population based studies of NSAID use and hepatic injury; frequency of clinically apparent liver injury from NSAIDs overall was ~10 cases per 100,000 patient-years of use, also being 10 per 100,000 for indomethacin) 9041931
Lacroix I, Lapeyre-Mestre M, Bagheri H, Pathak A, Montastruc JL; Club de Reflexion des cabinets de Groupe de Gastro-Enterologie (CREGG); General Practitioner Networks. Nonsteroidal anti-inflammatory drug-induced liver injury: a case-control study in primary care. Fundam Clin Pharmacol 2004; 18: 201-6. (Case controlled study of patients presenting with suspected drug induced liver injury in a general practice context in Southern France found 88 cases and used 178 population controls; 22 cases vs 16 controls were exposed to NSAIDs; 5 cases were attributed to diclofenac, 4 ibuprofen, 4 ketoprofen, 2 niflumic acid, 1 flurbiprofen and 1 meloxicam, but none to indomethacin). 15066135
Abraham C, Hart J, Locke SM, Baker AL. A case of indomethacin-induced acute hepatitis developing into chronic autoimmune hepatitis. Nat Clin Pract Gastroenterol Hepatol 2008; 5: 172-6. (47 year old woman with osteoarthritis developed acute hepatitis [bilirubin 5.3 rising to 30.7 mg/dL, ALT 1491 U/L, Alk P 414 U/L] within a few days of starting a 9 day course of indomethacin; symptoms [including ascites] and jaundice worsened despite stopping medication and prednisone was started with requirement for long term therapy [not resolving after >5 years]; biopsies suggested autoimmune hepatitis, but ANA and SMA were repeatedly negative). 18227818
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam, 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]; indomethacin not listed). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 7 were due to NSAIDs, including 4 attributed to bromfenac, 2 to diclofenac and 1 to etodolac, but none to indomethacin). 20949552
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; indomethacin is not discussed). 21128314
Mantarro S, Tuccori M, Pasqualetti G, Tognini S, Montagnani S, Monzani F, Blandizzi C. Acute portal vein thrombosis precipitated by indomethacin in a HCV-positive elderly patient. BMC Geriatr 2012; 12: 69. (79 year old man with chronic hepatitis C developed acute, symptomatic portal vein thrombosis with pain and ascites 11 days after starting indomethacin for back pain [bilirubin 1.2 mg/dL, ALT 74 U/L, GGT 36 U/L, INR 1.02], with eventual recovery on anticoagulation). 23148576
Van Eyken P, Nemolato S, Faa G, Ambu R. Hepatic injury to the newborn liver due to drugs. Curr Pharm Des 2012; 18: 3050-60. (Review of the hepatotoxicity of medications given to newborns mentions that indomethacin can cause clinically apparent liver injury, but that no such instances related to its intravenous use in newborns have been reported). 22564299
Lapeyre-Mestre M, Grolleau S, Montastruc JL; Adsociation Française des Centres Régionaux de Pharmacovigilance (CRPV). Adverse drug reactions associated with the use of NSAIDs: a case/noncase analysis of spontaneous reports from the French pharmacovigilance database 2002-2006. Fundam Clin Pharmacol 2013; 27: 223-30. (Analysis of 42,389 spontaneous serious adverse event reports to the French Pharmacovigilance database on 8 NSAIDs between 2002 and 2006; liver adverse events were most frequent with nimesulide [0.15 per million daily doses] compared to diclofenac [0.09], ketoprofen [0.09], piroxicam [0.06], naproxen [0.04], meloxicam [0.03], and tenoxicam [0.03]; indomethacin was not discussed). 21929527
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 6 attributed to diclofenac [ranking 2nd], but none for indomethacin or other NSAIDs). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common class of implicated agents being NSAIDS [n=62, 32%], but specific agents were nimesulide [n=53], piroxicam [5], diclofenac [2], gold salts [1], and naproxen [1]; indomethacin was not listed]). 24552865
Colomba C, Siracusa L, Madonia S, Bonura S, Rubino R. Irreversible acute renal failure and cholestatic hepatitis following therapy with indomethacin in an HIV-naive patient with pericarditis: a case report. Infez Med 2014; 22: 247-9. (54 year old man with newly diagnosed HIV infection developed renal failure and cholestatic hepatitis shortly after starting indomethacin, but also darunavir, ritonavir, tenofovir, emtricitabine, sulfamethoxazole, trimethoprim and azithromycin [bilirubin 0.3 rising to 16.7 mg/dL, ALT not given, Alk P 516 U/L, creatinine 2.4 rising to 5.4], resulting in death from renal failure despite dialysis). 25269969
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 were attributed to NSAIDs, but none to indomethacin [Schmeltzer 2016]). 25754159
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. (Among 1221 cases of drug induced liver injury enrolled in a prospective, US database between 2004 and 2014, 30 cases [2.5%] were attributed to NSAIDs, most common diclofenac; none were attributed to indomethacin). 26601797
Donati M, Conforti A, Lenti MC, Capuano A, Bortolami O, Motola D, Moretti U, et al; DILI-IT Study Group. Risk of acute and serious liver injury associated to nimesulide and other NSAIDs: data from drug-induced liver injury case-control study in Italy. Br J Clin Pharmacol 2016; 82: 238-48. (Among 179 cases of acute liver injury and 1770 controls admitted to 9 Italian hospitals between 2010 and 2014, NSAIDs used more frequently in cases compared to controls included nimesulide [17% vs 10%: odds ratio 1.88] and ibuprofen [14% vs 10%: odds ratio 1.59] and risk was higher in those taking higher doses; indomethacin was not mentioned). 26991794
Zoubek ME, González-Jimenez A, Medina-Cáliz I, Robles-Díaz M, Hernandez N, Romero-Gómez M, Bessone F, et al. High Prevalence of ibuprofen drug-induced Liver injury in Spanish and Latin-American registries. Clin Gastroenterol Hepatol 2018; 16: 292-294. (Analysis of a Spanish and Latin-American registries identified 73 cases of NSAID induced liver injury, the most common agents being nimesulide [38%], diclofenac [34%] and ibuprofen [17%], indomethacin was not mentioned). 28782674
Tujios SR, Lee WM. Acute liver failure induced by idiosyncratic reaction to drugs: challenges in diagnosis and therapy. Liver Int 2018; 38: 6-14. (Review of acute liver failure and the contribution of drug induced liver injury, of which 5% were due to NSAIDs, most commonly diclofenac and etodolac; no mention of indomethacin). 28771932
Meunier L, Larrey D. Recent advances in hepatotoxicity of non-steroidal anti-inflammatory drugs. Ann Hepatol 2018; 17: 187-91. (Review of the hepatotoxicity of NSAIDS mentions the most commonly implicated are diclofenac, nimesulide, sulindac, ibuprofen, piroxicam, naproxen and aspirin and that instances of cross sensitivity to liver injury have been reported between indomethacin and sulidac, another acetic acid derivative). 29469052
Sriuttha P, Sirichanchuen B, Permsuwan U. Hepatotoxicity of nonsteroidal anti-inflammatory drugs: a systematic review of randomized controlled trials. Int J Hepatol. 2018;2018:5253623.. (Systematic review of randomized controlled trials of NSAIDs that reported monitoring for hepatoxicity identified 18 studies but only 3 NSAIDs showed an increase rates of liver injury with the drug compared to placebo, including diclofenac, celecoxib, and etoricoxib; a single trial of indomethacin vs fenoprofen found no evidence of hepatotoxicity). 29568654
Nonopioid drugs for pain. Med Lett Drugs Ther. 2022;64(1645):33-40.. (Concise review of the nonopioid drugs for pain mentions that NSAIDs are considered to be more effective than acetaminophen for mild to moderate pain and that they can cause small increases in serum aminotransferase levels but that serious hepatotoxicity is rare, occurring most frequently with diclofenac, while cholestatic hepatitis has been reported with use of celecoxib, indomethacin is not mentioned as it is not approved for pain other than arthritic). 35231019
Ma J, Björnsson ES, Chalasani N. The safe use of analgesics in patients with cirrhosis: a narrative review. Am J Med. 2024;137:99-106.. (Review of the safety of analgesic use in patients with cirrhosis does not specifically discuss indomethacin). 37918778
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-update with genetic correlations. Liver Int. 2024;44:1409-1421.. (Among 55 cases of drug induced liver injury attributed to NSAIDs enrolled in a U.S. database between 2004 and 2022, 29 were attributed to diclofenac, 7 to celecoxib, 5 to ibuprofen, 4 to etodolac and meloxicam, 2 to oxaprozin, and 1 to naproxen and sulindac, but none to indomethacin). 38451034
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be attributed to prescribed medications, at rates for NSAIDs of 1:7,700 for sulindac, 1:8,300 for indomethacin, 1:9,100 for naproxen, 1:11,000 for ibuprofen, 1:12,500 for diclofenac, and 1:14,300 for celecoxib). 38913369
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver injury caused by prescription drugs. Drug Saf. 2025;48:151-160.. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study estimated incidence rates of 1 per 4,800 new persons treated each year with diclofenac, 1:25,000 for celecoxib, and 1 per 87,000 for meloxicam, but because no cases were attributed to indomethacin, incidence rates could not be estimated). 39317916
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 458 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, 49 were attributed to NSAIDs, including 19 [4.1%] to diclofenac, 14 [3.0%] to nimesulide and 11 [2.4%] to ibuprofen and 1 case each to celecoxib, ketoprofen, ketorolac, meloxicam, and piroxicam, but none to indomethacin [personal communication]). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Indomethacin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=indomethacin/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Indomethacin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=indomethacin)